# Lenacapavir

## OVERVIEW

### Introduction

Lenacapavir is a human immunodeficiency virus (HIV) capsid inhibitor that is used in combination with other antiretroviral agents as therapy of patients with multidrug resistant HIV infection. Lenacapavir has a long duration of action and is available as tablets for oral and in solution for subcutaneous administration, with an extended half-life and can be given every 26 weeks. Lenacapavir is associated with a low rate of transient and usually mild elevations in serum aminotransferase levels during therapy but has not been linked to cases of clinically apparent acute liver injury.

### Background

Lenacapavir (le nah kah’ pa veer) is an inhibitor of HIV capsid formation that is active in vitro and in vivo against HIV-1 replication, a first-in-class capsid inhibitor. Lenacapavir inhibits HIV replication in both early and late stages of the replicative cycle and is particularly useful based upon its activity against HIV strains that are resistant to standard antiviral agents. Initial approval of lenacapavir was based upon small trials of therapy of patients with multidrug resistant infections. In these studies, addition of lenacapavir to standard optimized therapy led to decreases in HIV viral levels by at least 0.5 log_10_ IU/mL. A long acting formulation was created using polyethylene glycol allowing for slow release of the drug from a subcutaneous depot that provides adequate drug levels for viral suppression for 26 weeks. Recommended regimens include a few days of oral followed by subcutaneous (sc) administration of the extended half-life formulation that is given every 26 weeks. Subsequent long term follow up demonstrated maintenance of viral inhibition in more than 80% of recipients. Lenacapavir was approved for use in patients with multidrug resistant HIV infection in 2022. Lenacapavir is available in tablets of 300 mg for initial oral administration and in solution as 463 mg in 1.5 mL single use vials for sc administration under the brand name Sunlenca. Two options are recommended for initiation of therapy. The first option is to start with oral lenacapavir alone in doses of 600 mg on days 1 and 2 and 300 mg on day 8, with sc lenacapavir (927 mg: 2 vials) starting on day 15 which is then continued in the maintenance phase of similar injections every 26 weeks. The second option is to start both oral (600 mg) and sc injections (927 mg) on day 1 with a second oral dose of 600 mg on day 2, followed by the maintenance phase of injections every 26 weeks. Lenacapavir is also being evaluated as preventive therapy in persons at high risk of acquiring HIV infection. In this situation, lenacapavir is administered subcutaneously (927 mg) every 26 weeks without an initial phase using the oral formulation. Lenacapavir is usually described as being well tolerated, side effects being uncommon and mild but possibly including nausea, constipation, diarrhea, abdominal distention, headache, and injection site reactions. Antiviral resistance develops in a proportion of patients treated long term. Serious adverse events are rare, although local reactions with nodule formation can lead to discontinuation.

### Hepatotoxicity

In the prelicensure small, open-label clinical trial, serum aminotransferase elevations occurred in 10% of patients and were above 5 times the ULN in 2 (3%), both of whom also developed jaundice. In both instances, however, other causes of liver injury were identified, one case being attributed to alcohol related hepatitis and the other to “reconstitution syndrome” caused by the restoration of immune reactivity with the successful control of HIV replication. Both patients were continued on lenacapavir and recovered uneventfully. Since its approval and more widescale use, there have been no published reports of liver injury attributed to lenacapavir. One of the shortcomings of a long acting pharmaceutical agent such as lenacapavir is the inability to stop therapy promptly in the event of toxicity or intolerance.

Finally, the restoration of immune reactivity as a result of adding lenacapavir to an antiretroviral regimen that is not fully effective can result in reconstitution syndrome and flares of chronic viral hepatitis in patients with preexisting chronic hepatitis B or C.

Likelihood score: E (unlikely cause of idiosyncratic clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which lenacapavir might cause liver injury is not known. It is metabolized in the liver, largely via CYP3A4, and it is potentially susceptible to drug-drug interactions, inhibitors of CYP3A4 leading to increased levels and, more importantly, inducers of CYP 3A4 causing a decrease in serum concentrations and increase in risk of virologic failure. Lenacapavir itself is a moderate inhibitor of CYP3A and can increase serum concentrations of CYP substrates, effects that can persist for up to 9 months after its subcutaneous administration.

### Outcome and Management

Serum aminotransferase elevations are common during lenacapavir therapy but mostly due to underlying, preexisting liver disease or other medications being taken by patients with chronic HIV infection. Routine monitoring of liver tests is not recommended in the product label. If aminotransferase elevations above 5 times the upper limit of normal (ULN) arise, other possible causes of liver injury should be sought and lenacapavir therapy should be interrupted only if levels remain elevated and unexplained. Because it is administered every 26 weeks, interruption of therapy is usually not possible, and full diagnostic evaluation and further follow up is usually available before a decision needs to be made.

Drug Class: Antiviral Agents

Other Drugs for Multidrug Resistant HIV Infection: Fostemsavir, Ibalizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lenacapavir – Sunlenca®

DRUG CLASS

Antiviral agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Lenacapavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Lenacapavir | 2189684-44-2 | C39-H32-ClF10-N7-O5-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 15 January 2025

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of lenacapavir).
Nunez M. Antiretroviral drugs. Hepatotoxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 506-510. (Review of hepatotoxicity of drugs for HIV infection; discusses several drugs for HIV but not lenacapavir).
Flexner CW. Antiretroviral agents and treatment of HIV Infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-1158. (Textbook of pharmacology and therapeutics; lenacapavir is not discussed).
FDA. Integrated Review.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/215973,215974Orig1s000IntegratedR.pdf (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy of lenacapavir, a first-in-class capsid inhibitor, mentions that ALT elevations arose in 15% of patients and were above 5 times ULN in 3%, 2 patients developing marked aminotransferase elevations with concurrent elevations in serum bilirubin, one case attributed to acute alcoholic hepatitis and the second to reconstitution syndrome, the abnormalities resolving spontaneously and both patients were able to continue lenacapavir).
Segal-Maurer S, DeJesus E, Stellbrink HJ, Castagna A, Richmond GJ, Sinclair GI, Siripassorn K, et al.; CAPELLA Study Investigators. Capsid inhibition with lenacapavir in multidrug-resistant HIV-1 infection. N Engl J Med. 2022;386:1793-1803. (Among 72 adults with multidrug resistant HIV-1 infection treated with daily oral lenacapavir followed by subcutaneous injections every 6 months added to their optimized antiretroviral regimen, HIV-1 RNA levels decreased by at least 0.5 log_10_ copies/mL within 2 weeks and suppression was maintained for at least 26 weeks when levels were less than 50 copies/mL in 82% of patients; therapy was without serious side effects, although 2 of 72 patients [3%] developed AST elevations above 5 times ULN [no details provided]). 35544387
Marrazzo J. Lenacapavir for HIV-1 - potential promise of a long-acting antiretroviral drug. N Engl J Med. 2022;386:1848-1849. (Editorial in response to Segal-Maurer et al [2022] stresses that lenacapavir is a first-in-class capsid inhibitor with two mechanisms of action, that it is long acting and given subcutaneously every 6 months, that side effects were uncommon except for injection site reactions, and that resistance was uncommon). 35544391
Paik J. Lenacapavir: first approval. Drugs. 2022;82:1499-1504. (Review of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of lenacapavir shortly after its approval for therapy of patients with multidrug resistant HIV-1 infection, mentions that it was generally well tolerated, the most frequent side effect being injection site reactions, and that 3% of patients had AST elevations and 3% direct bilirubin elevations). 36272024
Gupta SK, Berhe M, Crofoot G, Benson P, Ramgopal M, Sims J, McDonald C, et al. Lenacapavir administered every 26 weeks or daily in combination with oral daily antiretroviral therapy for initial treatment of HIV: a randomised, open-label, active-controlled, phase 2 trial. Lancet HIV. 2023;10:e15-e23. (Among 182 adults with previously untreated HIV infection started on various antiretroviral regimens with or without lenacapavir for 54 weeks, efficacy was similar with all four regimens). 36566079
Ogbuagu O, Segal-Maurer S, Ratanasuwan W, Avihingsanon A, Brinson C, Workowski K, Antinori A, et al.; GS-US-200-4625 investigators. Efficacy and safety of the novel capsid inhibitor lenacapavir to treat multidrug-resistant HIV: week 52 results of a phase 2/3 trial. Lancet HIV. 2023;10:e497-e505. (Among the 72 patients with multidrug resistant HIV infection treated with different regimens of lenacapavir added to optimized background regimens [Segal-Maurer 2022] who were followed to 52 weeks, 83-86% had a full virologic response, 9 patients having emergent lenacapavir resistance, 4 of whom subsequently had a full virologic response, and there were no new safety signals and no mention of ALT elevations or hepatotoxicity). 37451297
Lenacapavir (Sunlenca) for multidrug-resistant HIV. Med Lett Drugs Ther. 2023;65:68-70. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of lenacapavir shortly after its initial approval in the US as therapy for patients with multidrug resistant HIV-1 infection, mentions that elevations in liver enzyme levels have been reported and that immune reconstitution syndrome can occur). 37155250
Bekker LG, Das M, Abdool Karim Q, Ahmed K, Batting J, Brumskine W, et al.; PURPOSE 1 Study Team. Twice-Yearly Lenacapavir or Daily F/TAF for HIV Prevention in Cisgender Women. N Engl J Med. 2024;391:1179-1192. (Among 5338 adolescent and young women in South Africa and Uganda treated with lenacapavir [LEN: sc every 26 weeks] or emtricitabine [F] with either disoproxil fumarate [F/TDF] or alafenamide [F/TAF] orally once daily, 55 de novo, incident HIV infections arose, none on LEN, vs 39 on F/TAF [2.02/100 person years] and 16 on F/TDF [1.69/100 person-years], the adherence with the oral regimens was low; adverse events were similar among the 3 groups except for injection site reactions which were generally mild-moderate and none were scored as serious; rates of ALT elevations and hepatotoxicity not mentioned). 39046157
Ogbuagu O, Molina JM, Chetchotisakd P, Ramgopal MN, Sanchez W, Brunetta J, Castelli F, et al. Efficacy and safety of long-acting subcutaneous lenacapavir in heavily treatment-experienced people with multi-drug resistant HIV-1: week 104 results of a phase 2/3 trial. Clin Infect Dis. 2024:ciae423. Epub ahead of print. (Further follow up of the 72 patients with multidrug resistant HIV infection treated with different regimens of lenacapavir added to optimized background regimens [Segal-Maurer 2022] for 104 weeks, when 81-83% still had a full virologic response, 14 had lenacapavir resistance, and two had serum aminotransferase elevations above 5 times ULN). 39206943
Kelley CF, Acevedo-Quiñones M, Agwu AL, Avihingsanon A, Benson P, Blumenthal J, Brinson C, et al.; PURPOSE 2 Study Team. Twice-yearly lenacapavir for HIV prevention in men and gender-diverse persons. N Engl J Med. 2024 Nov 27. Epub ahead of print. (Among 3265 men [ages 16 and above] at high risk for HIV infection who were treated prophylactically with either lenacapavir [LEN: 927 mg subcutaneously every 26 weeks] or emtricitabine and tenofovir orally [F/TDF] once daily for 54 weeks, 2 cases arose in LEN-treated [0.10 per 100 person-years] vs 9 in F/TDF treated men [0.93 per 100 person-years], and adverse event rates were similar in the 2 groups, both total [74% vs 74%] and serious [3.3% vs 4.0%], and ALT elevations above 5 times ULN arose in 0.8% vs 0.6% most being considered unrelated).

## OTHER REFERENCE LINKS

1. Recent References on Lenacapavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Lenacapavir+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Lenacapavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lenacapavir)